# Herbalife

## OVERVIEW

### Introduction

Herbalife is weight management and nutritional supplement manufacturer that markets herbal and dietary supplements (HDS) for a wide range of conditions, including weight loss, digestive health, heart health, personal care, energy and fitness, general health, wellbeing, and boosting of energy and immunity. There have been many reports of acute, clinically apparent liver injury in persons taking Herbalife products, but the link to the HDS product has often been controversial. The specific ingredients in the various Herbalife products that might cause liver injury have not been identified.

### Background

Herbalife is a for-profit, publically traded company (Herbalife International of America, Inc., Torrance CA) that produces an array of multi-ingredient herbal and nutritional supplements (MINS). The products are not sold in conventional stores or nutrition outlets, but by independent distributors or via the internet. The constituents of the various Herbalife products vary but are largely proteins, amino acids, vitamins, minerals and selected botanicals such as aloe vera, green tea, ginseng, gingko, guarana, valerian, lavender, saw palmetto, echinacea, astragalus, ginger, hops, bilberry, vegetable and fruit extracts and many others. The ingredients and their concentrations in some of the products have been modified over time. Some of the more common products sold are listed in the Table below with a partial listing of their ingredients as provided in the product label. Because the products are considered nutritional supplements, they are not subject to the usual efficacy and safety evaluation given to medications. However, all nutritional supplements are subject to rules regarding purity and good manufacturing practices. Nutritional supplements are not recommended for specific medical conditions, but can be advertised as being supportive of general health, wellness and weight reduction. These multiingredient products appear to be generally safe and well tolerated, but prospective studies of their efficacy, tolerance and safety have not been published.

Selected Herbalife Products (April 2018)

Product Name | Condition | Major Listed Ingredients
Formula 1 Shake Mix: Healthy Meal | Weight control | Soy protein, fructose, cellulose powder, corn bran, guar gum, minerals, rice fiber, soy lecithin, canola oil, carrageenan, medium chain triglycerides, citrus pectin, psyllium husk powder, ginger root powder, proteases of Aspergillus, honey powder, ascorbic acid, dl-alpha tocopherol, papaya fruit, carotene, pantothenate, bromelain, papain powder, folic acid, pyridoxine, thiamine, riboflavin, cholecalciferol, cyanocobalamin and several minerals.
Formula 2 Multivitamin Complex | Healthy diet | Vitamins A, C, D, E, B6 and B12; thiamine, riboflavin, niacin, folate, biotin and pantothenic acid; calcium, iron, iodine, magnesium zinc, selenium, copper, manganese and chromium; potassium, vanadium, lycopene, and proprietary“herbal blend”
Formula 3 Cell Activator | Healthy diet | Alpha lipoic acid (150 mg), aloe vera concentrate (52 mg), shiitake mushroom (15 mg), pomegranate rind extract (11 mg), Rhodiola root extract (10 mg), dried pine bark extract (2 mg), resveratrol (0.9 mg)
Prolessa Duo | Weight control | Safflower, palm and oat oils; glucose syrup, sodium caseinate, silicon dioxide, ascorbyl palmitate, phosphates, soy lecithin, tocopherols, natural flavors
Total Control | Weight control | Ginger root, green tea leaf, oolong tea leaf, black tea leaf, and pomegranate rind powder extracts
Cell-U-Loss | Weight control | Corn silk (134 mg), parsley herb (10 mg), dandelion leaf (10 mg) and asparagus root extracts (5 mg); sodium, potassium, calcium and magnesium
Tri-shield | Heart health | Vitamin E (2 IU), Neptune Krill Oil (300 mg), Omega-3 fatty acids (45 mg).
Core Complex with CoQ10 Plus | Heart health | Vitamin D (600 IU), E (18 IU), B6 (4 mg) and B12 (12 mg), marine lipid complex (fish oil: 1.5 g), phytosterol esters (1.3 g), omega-3 fatty acids (717 mg), Neptune Krill Oil (300 mg), hawthorn fruit extract (30 mg), coenzyme Q10 (100 mg)
Herbalifeline | Heart health | Vitamin E (8 IU), marine lipid complex (fish oil: 758 mg), Omega-3 fatty acids (from fish Oil: 336 mg)
Niteworks Powder Mix | Heart health | Vitamin C (500 mg), vitamin E (200 IU), folate (400 mcg), calcium (66 mg), proprietary protein blend (L-arginine, L-citruline: 5.2 g), L-taurine (300 mg), lemon balm extract (50 mg), alpha lipoic acid (10 mg)
Mega Garlic Plus | Heart health | Vitamin C (70 mg), calcium (44 mg), phosphorus (34 mg), garlic power (600 mg)
CoQ10 Plus Softgel | Heart health | Vitamin D (600 IU), coenzyme Q10 (100 mg), docosahexaenoic acid (from Algal oil: 100 mg), Hawthorn fruit extract (30 mg)
Xtra-Cal Advanced | Women’s health | Vitamin D (134 IU), calcium (334 mg), magnesium (67 mg), zinc (2.5 mg), copper (.33 mg), manganese (.33 mg), boron (167 mg), herbal blend (20 mg) [tumeric root and rose hips powder]
Woman’s Choice | Women’s health | Soy isoflavone (150 mg), kudzu extract (75 mg), chaste berry extract (40 mg)
Triple Berry Complex | Women’s health | Cranberry Powder (510 mg), bilberry extract (51 mg), blueberry powder (51 mg)
Tang Kuei Plus | Women’s health | Vitamin C (8 mg), Tang Kuei root extract (200 mg), passion flower extract (30 mg)
Ultimate Prostate Formula | Men’s health | Vitamin E (12.5 IU), selenium (12.5 mcg), saw palmetto lipid extract (160 mg), pumpkin seed oil (50 mg), lycopene (tomato extract: 0.5 mg)
Male Factor 1000 | Men’s health | Vitamin C (50 mg), calcium carbonate (96 mg), male factor blend (380 mg): [Green Oat, Nettle Leaf, Sea Buckthorn Juice, Clycine, Dextrose, Asian Ginseng, Eleuthero Extract]
Prelox Blue | Male sexual performance enhancer | Protein (2 g), L-arginine, aspartic acid, L-taurine, pycnogenol (dried pine bark extract)
Ultimate Prostate Formula | Prostate health | Vitamin E (12.5 IU), selenium (12.5 mcg), saw palmetto lipid extract (160 mg), pumpkin seed oil (50 mg), lycopene (tomato extract: 0.5 mg)
Kid’s Shakes | Children’s health | Soy protein, fructose, sugar, maize dextrin, whey protein. Vitamins A, C, D, E, B6, B12, calcium, iron, thiamine, riboflavin, folate, biotin, pantothenic acid, phosphorus, magnesium, zinc
Multivites | Children’s health | Vitamins A (2500 IU), C, D, E, B6 and B12, thiamine, riboflavin, niacin, folate, biotin, pantothenic acid, calcium, iron, magnesium, zinc
Kindermins | Children’s health | Vitamin A (1500 IU), C, D, E, B6 and B12, thiamine, riboflavin, niacin, folate, biotin, pantothenic acid, calcium, iron (7.5 mg), magnesium, zinc
Joint Support Advanced | Joint health | Selenium (23.3 mcg), copper (0.33 mg), manganese (0.67 mg), glucosamine (500 mg), Scutellaria baicalensis extract (160 mg)
Ocular Defense Formula | Ocular health | Vitamin A (1250 IU), C (80 mg), and E (7.5 IU), selenium (22.5 mcg), copper (0.45 mg), lutein (6 mg).
Active Fiber Complex | Digestive health | Sugarcane fiber, maize dextrin, maltodextrin, citrus fiber, soy fiber, inulin, carboxymethycellulose, silicon dioxide (total 5 g of fiber)
Herbal Aloe Powder & Concentrate | Digestive health | Aloe vera concentrate (inner leaf)
Florafiber | Digestive health | Cellulose powder, microcrystalline cellulose, dicalcium phosphate, stearic acid, apple pectin, psyllium seed, lactobacillus acidophilus
21 day Herbal Cleansing Program | Digestive health | Calcium (150 mg), herbal blend of milk thistle extract, insulin, beet root, lactobacillus acidophilus, hesperidin complex, apple pectin, lemon pectin, chamomile extract
Garden 7 Phytonutrient Supplement | Immune health | Vitamin A (1676 IU) and C (65 mg), calcium, riboflavin, garlic, carrot, broccoli and spinach powder, Hesperidin, quercetin, grape skin and cranberry extract, allicin, lycopene, lutein, zeaxanthin
RoseGuard | Environmental toxin defense | Vitamin A (2500 IU), C (30 mg) and E (15 IU), calcium (33 mg), Astragalus root (510 mg), rosemary leaf (210 mg) and turmeric root (80 mg) extracts.
Schizandra Plus | Immune support | Vitamin A (2500 IU), C (40 mg), E (20 IU) and B6 (10 mg); calcium (16 mg) and selenium (35 mcg). Schizandra extract (120 mg)
Best Defense | Immune boosting | Vitamin C (1000 mg), zinc (7.5 mg), and herbal blend of Echinacea purpurea, Echinacea angustifolia, Astragalus, Schisandra, ginger and maltodextrin.
Relax Now | Stress | Jujube (seed: 250 mg), ashwagandha (root: 100 mg) and passionflower extracts (aerial part: 75 mg).
Sleep Now | Stress | Calcium (144 mg) and blend of herbs including passionflower, valerian, hops, wild lettuce, cinnamon, orange peel, lavender (flower) and amla extract
H3O Fitness Drink | Energy and fitness | Vitamins A, C, and E, calcium and magnesium with trehalose dehydrate and sugar (12 g)
Liftoff | Energy and fitness | Vitamins C (60 mg), B6 (6 mg) and B12 (12 mcg); thiamine (3 mg), riboflavin (1.7 mg), niacin (20 mg), biotin (300 mg), and pantothenic acid (20 mg), sodium, potassium and an energy blend (393 mg) of L-taurine, Panax ginseng root, caffeine, Ginkgo biloba extract, guarana extract and inositol.
N-R-G Nature’s Raw Guarana Tea or Tablets | Energy and fitness | Calcium (202 mg) and guarana seed blend (800 mg).
Green Tea | Hydration | Green tea extract (25 mg of caffeine) for brewing tea
Herbalife 24 Formula 1 Sport | Nutrition for Athletes | Vitamins A, C, D, E, B6 and B12; calcium, iron; thiamine, riboflavin, niacin, folate, pantothenic acid, phosphorus, magnesium, zinc, copper and chromium with milk protein concentrate, fructose, sugar and sunflower oil.

### Hepatotoxicity

The initial reports of liver injury attributed to Herbalife were from Spain and Israel, with subsequent case series from Latin America, Switzerland, Iceland and the United States. At least 50 instances of clinically apparent liver injury have been described in persons taking Herbalife products. The typical latency has ranged from 1 month to more than a year, the average being 2 to 9 months. The onset is usually insidious with fatigue, nausea, abdominal discomfort, followed by dark urine and jaundice. The pattern of serum enzyme elevations is usually hepatocellular with marked elevations in ALT, but only modest increases in alkaline phosphatase. Occasional cases with a mixed pattern of injury have been described and some cases have been called “cholestatic”, largely on the basis of liver histology rather than serum enzyme elevations. Immunoallergic features and autoimmune markers were not common. Resolution occurred upon withdrawal and several instances of relapse with restarting a Herbalife product have been described, although details of the rechallenge are rarely given, largely because the rechallenge was not intentional but a result of the patient restarting the medication on their own and without medical supervision. Liver histology has been variable, but usually shows acute hepatitis with cholestatic features. At least one instance with changes of sinusoidal obstruction syndrome has been described.

A major difficulty in assessing cases of liver injury possibly due to a Herbalife product is that most patients are taking more than one preparation (some as many as 12) and each product contains multiple nutritional supplements and botanicals. Some of the products contain green tea and others aloe vera, but the concentrations of these herbals are not always clear and they appear to have decreased in recent years. Because of the many components in these multi-ingredient nutritional supplements, it is difficult to attribute the liver injury to any specific substance listed on the product labels. The components of the products change and green tea is no longer listed as a constituent of the core products. The number of cases of liver injury attributable to Herbalife products appears to have decreased since their introduction.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury attributed to Herbalife products remains unexplained. There was no clear commonality in the products themselves, much less their constituents. Some products contained green tea or aloe vera extracts, both which have been implicated in other forms of HDS liver injury.

### Outcome and Management

The liver injury that has been attributed to Herbalife products has usually been mild-to-moderate in severity and self-limited in course, resolving in 1 to 2 months of stopping the preparations. Rare instances of acute liver failure and even progressive fibrosis and cirrhosis have been reported, but are uncommon and not always completely well documented. Nevertheless, in patients presenting with acute or chronic, unexplained liver injury, all HDS products should be discontinued and the case reported to federal registries. It is also helpful to carefully define what products were being taken and at what doses and for how long. Retrieval of the actual product or products can also be helpful as progress is being made in the identification of ingredients by advanced chemical and biochemical methods.

Drug Class: Herbal and Dietary Supplements, Nutritional Supplements, Multi-Ingredient

## CASE REPORT

### Case 1. Acute hepatitis after use of several Herbalife Products.

[Modified from: Chen GC, Ramanathan VS, Law D, Funchain P, Chen GC, French S, Shlopov B, et al. Acute liver injury induced by weight-loss herbal supplements. World J Hepatol 2010; 2: 410-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21173910)]

A 37 year old woman developed nausea, epigastric pain and jaundice approximately 2 months after starting several Herbalife dietary supplements for weight loss. The supplements mentioned included Formula One Shake Mix, [Formula Two] Multivitamin Complex, [Formula Three] Cell Activator, Cell-U-loss, Herbal Concentrate Original and Total Control Formula. She had no previous history of liver disease and denied alcohol and drug abuse. On presentation one month after onset of symptoms, she was jaundiced, but had no fever, rash or signs of chronic liver disease. Laboratory tests showed marked elevations in ALT (2068 U/L) and AST (2199 U/L) with minimal increase in alkaline phosphatase (185 U/L) and a total bilirubin of 15.3 mg/dL. She was admitted for evaluation. Tests for hepatitis A, B, C, E, EBV and cytomegalovirus were negative as were routine autoantibodies. Immunoglobulin levels were normal. An abdominal CT scan showed no evidence of biliary obstruction. A liver biopsy showed an acute hepatocellular injury with bridging fibrosis. Once the supplements were stopped, she improved slowly and was discharged one week later without evidence of worsening liver disease, hepatic encephalopathy or hypoglycemia (Table). Subsequently, her symptoms resolved and laboratory tests had returned to normal or near normal levels when she was seen two months later.

#### Key Points

Medication: | Multiple Herbalife products
Pattern: | Hepatocellular (R=39)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 months
Recovery: | approximately 2 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
3 months | 0 | 2068 | 185 | 15.3 | Admitted. INR normal
| 8 days | 1501 | 183 | 29.9 | Discharged
5 months | 2 months | 43 | 65 | 1.1 | Outpatient clinic
Normal Values | | <35 | <126 | <1.2

#### Comment

A case of drug induced liver injury in a woman in a weight loss program using multiple Herbalife products. No other possible cause of liver injury was identified. The agent responsible in the numerous dietary supplements that she was taking could not be identified. The injury was distinctly hepatocellular and viral-hepatitis like and resembled the typical injury associated with green tea. She worsened for the first week after stopping the nutritional supplements but improved thereafter, and all tests were normal or near normal two months later.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Herbalife®

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Herbalife)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Herbalife | Not Applicable | Herbal Mixture | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 11 April 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; Herbalife products are not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that there have been 6 published reports of 34 cases of liver injury attributed to Herbalife products from Argentina, Iceland, Israel, Spain and Switzerland, usually with a hepatocellular pattern of injury and some cases being severe and causing cirrhosis or need for liver transplantation; the patients were taking up to 17 different Herbalife products and the specific substances responsible were unknown).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, but the specific botanical substances implicated were not listed). 15390328
Elinav E, Pinsker G, Safadi R, Pappo O, Bromberg M, Anis E, Keinan-Boker L, et al. Association between consumption of Herbalife nutritional supplements and acute hepatotoxicity. J Hepatol 2007; 47: 514-20. (Description of 12 cases of liver injury attributed to Herbalife products in Israel identified by a Ministry of Health investigation: 11 women, 1 man, ages 32-78 years, onset after 2-35 months [mean=11 months], typically with a hepatocellular pattern of enzyme elevations [mean peak bilirubin 9.1 mg/dL, ALT 1481 U/L, Alk P 282 U/L], 1 with ANA resolving on recovery; 11 patients recovered, one died of hepatitis B reactivation, 3 redeveloped liver injury upon reexposure). 17692424
Schoepfer AM, Engel A, Fattinger K, Marbet UA, Criblez D, Reichen J, Zimmermann A, et al. Herbal does not mean innocuous: ten cases of severe hepatotoxicity associated with dietary supplements from Herbalife products. J Hepatol 2007; 47: 521-6. (Description of 10 cases of liver injury attributed to Herbalife weight loss products identified in a survey of Swiss hospitals: 4 men and 6 women, ages 30-69 years, with onset after 2-144 months [median=5 months], typically with a hepatocellular pattern of enzyme elevations and 9 with jaundice [bilirubin 0.4-28.2 mg/dL, ALT 4-50 times ULN, Alk P 1.1-6.5 times ULN], 2 with recurrence on rechallenge, 3 requiring liver transplant, 1 with sinusoidal obstruction syndrome, 1 with cirrhosis). 17692989
Stickel F. Slimming at all costs: Herbalife-induced liver injury. J Hepatol 2007; 47: 444-6. (Editorial in response to Schoepfer [2007] and Elinay [2007] discussing the difficulties in assigning causality and identifying the toxic component, many patients take multiple herbal products and each one may include multiple components, and the product may also contain contaminants or a botanical that is not on the label). 17692988
Duque JM, Ferreiro J, Salgueiro E, Manso G. [Hepatotoxicity associated with the consumption of herbal slimming products]. Med Clin (Barc) 2007; 128: 238-9. Spanish. (Description of 3 cases of liver injury arising during use of Herbalife products from Spain, 3 women ages 49-54 years, with onset after 1, 6 and 36 months of starting the products [bilirubin 0.7, 0.8 and 26.7 mg/dL, ALT 138, 505 and 1890 U/L, Alk P 112, 166 and 425 U/L], resolving upon stopping in all three). 17335732
Chitturi S, Farrell GC. Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol 2008; 23: 366-73. (Review of hepatotoxicity of herbal medications focusing upon those used for weight loss including nitroso-fenfluramine, usnic acid, ephedra, germander, skullcap, green tea and Herbalife products). 18318821
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig 2008; 100: 688-95. (Among 521 cases of drug induced liver injury submitted to a Spanish registry between 1994 and 2006, 13 [2%] were attributed to herbal remedies, but no Herbalife product was implicated). 19159172
Chao S, Anders M, Turbay M, Olaiz E, Mc Cormack L, Mastai R. [Toxic hepatitis by consumption of Herbalife products: a case report]. Acta Gastroenterol Latinoam 2008; 38: 274-7. Spanish. (63 year old Argentinean woman developed jaundice and pruritus 2.5 months after starting Herbalife products [peak bilirubin 17.5 mg/dL, ALT 847 U/L, Alk P 3 times ULN], resolving within 5 months of stopping). 19157382
Manso G, López-Rivas L, Duque JM, Salgueiro E. Spanish reports of hepatotoxicity associated with Herbalife products. J Hepatol 2008; 49: 289-90; author reply 290-1. (Discussion of 4 cases of Herbalife hepatotoxicity from Spain [3 reported by Duque 2007], 2 occurring in sisters, suggesting a genetic propensity and an idiosyncratic drug reaction). 18571274
Ignarro L, Heber D, Henig YS, Bejar E. Herbalife nutritional products and liver injury revisited. J Hepatol 2008; 49: 291-3; author reply 293-4. (Comment on publications on Herbalife hepatotoxicity [Elinav and Schoepfer 2007] from the sponsor, questioning whether their product was involved, because the product has been used safely and without reports of liver injury by millions). 18550201
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, 2 cases being attributed to Herbalife products). 18955056
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; specific discussion of green tea, Hydroxycut, Herbalife and traditional Chinese herbal medicines). 19826971
Stickel F, Droz S, Patsenker E, Bögli-Stuber K, Aebi B, Leib SL. Severe hepatotoxicity following ingestion of Herbalife nutritional supplements contaminated with Bacillus subtilis. J Hepatol. 2009; 50: 111-7. (78 year old man and 50 year old woman developed jaundice having used Herbalife products for 3 and 1 years [bilirubin 35.7 and 4.9 mg/dL, ALT 2339 and 128 U/L, Alk P 168 and 597 U/L, ANA 1:1280 and 1:160], ultimately resolving after stopping the commercial products, one with concurrent prednisolone and one with ursodiol therapy; testing of 4 samples of Herbalife products revealed growth of bacillus subtilis). 19010564
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbal products to a Swedish Registry found 31 with increased liver enzymes, 26 with elevated aminotransferase levels, 22 with mixed liver reaction and 12 with hepatitis; agents implicated in causing liver injury included valerian, ginseng, green tea, and aloe vera; no mention of Herbalife products). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to HDS, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut; Herbalife products were not mentioned). 20949552
Chen GC, Ramanathan VS, Law D, Funchain P, Chen GC, French S, Shlopov B, et al. Acute liver injury induced by weight-loss herbal supplements. World J Hepatol 2010; 2: 410-5. (Description of 3 women, ages 31, 37 and 53 years, taking Hydroxycut [n=1] or Herbalife [n=2] products for weight loss who developed jaundice 3, 4 and 12 months after starting [bilirubin 15.3, 29.9, and 18.2 mg/dL, ALT 1227, 2068 and 983 U/L, Alk P 268, 185 and 292 U/L], resolving within 2-3 months of stopping: Case 1). 21173910
Appelhans K, Smith C, Bejar E, Henig YS. Revisiting acute liver injury associated with herbalife products. World J Hepatol 2011; 3: 275-7. (Letter in response to Chen [2010] arguing that the two cases attributed to Herbalife products were inadequately documented and that the previously reported studies showing Bacillus subtilis contamination in Herbalife products [Stickel 2009] were poorly documented and inadequately controlled). 22059112
Stiefelhagen P. ["Doing something good" for the body? Definitely not! Liver damage caused by food supplements]. MMW Fortschr Med 2010; 152: 21. German. (News report on liver injury due to nutritional supplements such as Herbalife products [at least 22 cases being reported between 1998 and 2004] and Hydroxycut products). 21174361
Jóhannsson M, Ormarsdóttir S, Olafsson S. [Hepatotoxicity associated with the use of Herbalife]. Laeknabladid 2010; 96: 167-72. Icelandic. (Description of 5 cases of liver injury attributed to Herbalife products from Iceland; 4 women and 1 man, ages 29-78 years with onset after 1-7 months of use [bilirubin 1.3 to 15.6 mg/dL, ALT 456 to 2637 U/L, Alk P 149 to 712 U/L], all recovering upon stopping). 20197595
Stickel F, Kessebohm K, Weimann R, Seitz HK. Review of liver injury associated with dietary supplements. Liver Int 2011; 31: 595-605. (Review of current understanding of liver injury from HDS focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids). 21457433
Appelhans K, Goldstein LI. Revisiting liver injury associated with dietary supplements. Liver Int 2011; 31: 1239-40. (Letter in response to review article by Stickel [2011] stating that Herbalife has cooperated with 25 regulatory agencies investigating possible hepatotoxicity of their products and none subsequently took any actions; reply by authors mentions that numerous case reports have established a causal role of Herbalife products with liver injury). 21745293
Manso G, López-Rivas L, Salgueiro ME, Duque JM, Jimeno FJ, Andrade RJ, Lucena MI. Continuous reporting of new cases in Spain supports the relationship between Herbalife® products and liver injury. Pharmacoepidemiol Drug Saf 2011; 20: 1080-7. (Update on cases of liver injury reported to the Spanish Pharmacovigilance Database between 2003-2010 identified 20 cases of liver injury possibly due to Herbalife products; 16 in women, mean age 45 years, 12 hospitalized [bilirubin 0.6 to 33.3 mg/dL, ALT 88 to 3269 U/L, Alk P 112 to 1034 U/L]; one patient developed cirrhosis, the others recovered; 1 to 9 different Herbalife products were implicated and no single ingredient appeared common to most cases). 21751292
Appelhans K, Frankos V, Shao A. Misconceptions regarding the association between Herbalife products and liver-related case reports in Spain. Pharmacoepidemiol Drug Saf 2012; 21: 333-4; author reply 335. (Letter in response to Manso [2011] from the sponsor arguing that the causality process used was faulty and that application of WHO criteria would weaken the scoring of cases to conditional or only possibly related to the Herbalife products). 22407600
Larrey D, Faure S. Herbal medicine hepatotoxicity: a new step with development of specific biomarkers. J Hepatol 2011; 54: 599-601. (Editorial on the problem of hepatotoxicity of herbal medications, the difficulties of causality assessment, variability of the products, possibly of contamination, lack of rigorous regulations and need for biomarkers for hepatic injury). 21167851
Appelhans K, Frankos V. Herbal medicine hepatotoxicity revisited. J Hepatol 2012; 56: 504-5. Reply by authors. (Letter in response to Larrey [2011] from the sponsor arguing that Herbalife products are carefully assessed for purity and that the green tea extracts used have never been implicated in causing liver injury; authors reply that idiosyncratic liver injury occurs with many medications of proven purity). 21782760
Ramanathan VS, Hensley G, French S, Eysselein V, Chung D, Reicher S, Pham B. Hypervitaminosis A inducing intra-hepatic cholestasis--a rare case report. Exp Mol Pathol 2010; 88: 324-5. (46 year old man who had been taking Herbalife products including multivitamins for 12 years developed jaundice and pruritus [bilirubin 11.2 mg/dL, ALT 68 U/L, Alk P 193 U/L], with a liver biopsy showing fat vacuoles in stellate cells suggestive of vitamin A toxicity; stopping the dietary supplements and avoiding excess vitamin A was followed by resolution of the liver injury). 19944093
Bejar E, Smith CR, Appelhans K, Henig YS. Correcting a misrepresentation of hypervitaminosis A attributed to Herbalife product consumption. Exp Mol Pathol 2011; 90: 320-1; author reply 322. (Letter in response to Ramanathan [2010] from the sponsor of Herbalife arguing that the calculation of the total vitamin A in the products taken was incorrect [3417 instead to 5082 IU daily] and within the upper limits of tolerance for vitamin A). 21315714
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including 19 publications on green tea, 13 on Herbalife and 6 on Hydroxycut products). 22928722
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury mentions that Herbalife products have been associated with at least 34 published cases of liver injury, the pattern of injury being hepatocellular in most cases, severity ranging from mild-to-severe and fatal, and most case being scored as only probable although a few had recurrence upon rechallenge). 23121117
Appelhans K, Najeeullah R, Frankos V. Letter: retrospective reviews of liver-related case reports allegedly associated with Herbalife present insufficient and inaccurate data. Aliment Pharmacol Ther 2013; 37: 753-4. (Letter in response to Bunchorntavakul [2013] from the sponsor arguing that their review article was inaccurate in regard to Herbalife products, because the authors did not adequately assess whether the reported cases were sufficiently documented). 23458533
Reddy KR, Bunchorntavakul C. Letter: retrospective reviews of liver-related case reports allegedly associated with Herbalife present insufficient and inaccurate data--authors' reply. Aliment Pharmacol Ther 2013; 37: 754-5. (Reply to Appelhans [2013] by the authors stating that the weight of the evidence is strongly in favor of a hepatotoxic potential of some of the commercial Herbalife products). 23458534
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol 2013; 25: 1093-8. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%] and that these other diagnoses weakened the causality assessment in most instances). 23510966
Teschke R, Frenzel C, Schulze J, Schwarzenboeck A, Eickhoff A. Herbalife hepatotoxicity: Evaluation of cases with positive reexposure tests. World J Hepatol 2013; 5: 353-63. (Analysis of the published literature of outcome of rechallenge after suspected HDS hepatotoxicity identified 53 cases, 8 of which mentioned a positive rechallenge; however, documentation of the timing and results of rechallenge was frequently missing and only one case was suitably documented to judge the rechallenge using the RUCAM causality method). 23898368
Teschke R, Eickhoff A, Wolff A, Frenzel C, Schulze J. Herbal hepatotoxicity and WHO global introspection method. Ann Hepatol 2013; 12: 11-21. (Commentary on the WHO global introspection method for assessing causality in HDS induced liver injury, arguing the superiority of the RUCAM method because of its specificity for liver injury and attention to alternative explanations, such as hepatitis and other viral infections). 23293189
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 5 attributed to Herbalife products only one of which was icteric [bilirubin 0.3 to 3.6 mg/dL, ALT 223 to 859 U/L, Alk P 95 to 346 U/L], all resolving after the product was stopped). 23419359
Licata A, Macaluso FS, Craxì A. Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med 2013; 8: 13-22. (Review and commentary on herbal hepatotoxicity discusses pyrrolizidine alkaloids, green tea, Echinacea, kava, usnic acid, ephedra and products made by Herbalife, Hydroxycut and LipoKinetix). 22477279
Appelhans K, Najeeullah R, Frankos V. Considerations regarding the alleged association between Herbalife products and cases of hepatotoxicity. . Intern Emerg Med 2014; 9: 599-600. (Letter in response to Licata [2012] from the sponsor regarding the listing of Herbalife with other products implicated in causing liver injury, arguing that there are more than 100 Herbalife products which are mostly dietary supplements and foods and no specific herbal component has been identified in their products that causes liver injury). 24470142
Licata A, Craxì A. Considerations regarding the alleged association between Herbalife products and cases of hepatotoxicity: a rebuttal. Intern Emerg Med 2014; 9 (5): 601-2. (Reply to Appelhans [2014] indicating that the hepatic injury is probably idiosyncratic in nature and that the possibly responsible ingredient in Herbalife products cannot be identified because of their changing nature and many ingredients). 24570131
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 130 cases of HDS associated liver injury enrolled in a US prospective study between 2004 and 2013, four [3%] were attributed to Herbalife products). 25043597
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment: mentions Herbalife products as being implicated in cases of acute hepatocellular injury). 24099027
Rossi S, Navarro VJ. Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol 2014; 12: 1069-76. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions Herbalife products as being implicated in case series of liver injury from Israel, Switzerland and Spain). 23924877
Navarro VJ, Lucena MI. Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis 2014; 34: 172-93. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions Herbalife products as having been implicated in cases of acute hepatocellular liver injury, some with a positive rechallenge). 24879982
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-532. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that multi-ingredient supplements have been implicated in many cases of liver injury including proprietary agents marketed under the names Herbalife, Hydroxycut and OxyELITE Pro). 25500423
Stickel F, Shouval D. Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol 2015; 89: 851-65. (Extensive review of liver injury due to HDS mentions that Herbalife has been implicated in 54 cases of liver injury, 7 with a positive rechallenge, but that the cause of the injury remains unknown and that few cases have been published since 2011). 25680499
Korth C. Drug-induced hepatotoxicity of select herbal therapies. J Pharm Pract 2014; 27: 567-72. (Review of liver injury due to selected HDS discusses the literature implicating kava, green tea, germander, pyrrolizidine alkaloids and Herbalife products). 25546878
Appelhans K, Najeeullah R, Frankos V. Deficiencies identified in dated case reports associated with Herbalife. J Pharm Pract 2015; 28: 484-5. (Letter in response to a review article [Korth 2014] from the sponsor arguing that many of the cases of liver injury attributed to Herbalife products were deficient, citing 10 letters to the editor from the sponsor to support the claim). 26272932
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], of which 4 [0.5%] were attributed to Herbalife products). 25754159
Mengual-Moreno E, Lizarzábal-García M, Ruiz-Soler M, Silva-Suarez N, Andrade-Bellido R, Lucena-González M, Bessone F, et al. [Case reports of drug-induced liver injury in a reference hospital of Zulia state, Venezuela]. Invest Clin 2015; 56: 3-12. (Among 13 cases of drug induced liver injury seen at a single Venezuelan medical center during 2012-13, the most commonly implicated agents were ibuprofen [n=3], acetaminophen [n=3], isoniazid [n=2] and Herbalife products [n=2, one of which was fatal]). 25920181
Zheng EX, Navarro VJ. Liver injury from herbal, dietary, and weight loss supplements: a review. J Clin Transl Hepatol 2015; 3: 93-8. (Review and commentary on liver injury attributed to weight loss HDS products focusing upon Hydroxycut and OxyELITE Pro and discussing the possible hepatotoxicity of specific herbal weight loss agents, Camellia sinesis [green tea], usnic acid, Garcinia cambogia, Ma Huang [ephedra] and Aegle marmelos [aegeline]). 26357638
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by Dietary Supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17(4). pii: E537. (Listing of published cases of liver injury from HDS products including 11 reports describing a total of 57 cases attributed to Herbalife products published between 2004 and 2015). 27070596
Avigan MI, Mozersky RP, Seeff LB. Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci 2016; 17: 331. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26950122) (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against Hydroxycut, Lipokinetix and OxyELITE Pro when reports of liver injury appeared in postmarketing phase).
Marcus DM. Dietary supplements: What's in a name? What's in the bottle? Drug Test Anal 2016; 8 (3-4): 410-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27072845) (Commentary on regulation of HDS products concludes: "the marketing of botanical supplements is based on unfounded claims that they are safe and effective", and "there is no reason to take herbal medicines whose composition and benefits are unknown and whose risks are evident").
Rios FF, Rodrigues de Freitas LA, Codes L, Santos Junior GO, Schinoni MI, et al. Hepatoportal sclerosis related to the use of herbals and nutritional supplements. Causality or coincidence? Ann Hepatol 2016; 15: 932-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27740529) (Two women, ages 42 and 54, who were taking Herbalife products for 3 and 12 months developed abdominal discomfort, fatigue and abnormal liver tests and were found to have nodular regenerative hyperplasia, having no other risk factors except occasional use of herbal teas).
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 46 published cases of green tea associated liver injury and concludes that green tea may warrant a warning label). 27402097
Wong LL, Lacar L, Roytman M, Orloff SL. Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc 2017; 49: 322-5. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products). 28219592
de Boer YS, Sherker AH. Herbal and dietary supplement-induced liver injury. Clin Liver Dis 2017; 21: 135-49. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, kava, pyrrolizidine alkaloids and proprietary multiingredient nutrition supplements [MINS] such as Herbalife products). 27842768
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al; Drug Induced Liver Injury Network (DILIN). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf 2017; 40: 783-7. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient supplements, but none were Herbalife products). 28555362
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products and challenges for future research concludes that stronger regulations are needed to address the increasing number of cases of HDS induced liver injury, particularly those linked to use of multiingredient dietary supplements such as Herbalife products). 27677775
Hu J, Webster D, Cao J, Shao A. The safety of green tea and green tea extracts consumption in adults - results of a systematic review. Regul Toxicol Pharmacol 2018 Mar 23.[Epub ahead of print] (Extensive review of published toxicology of green tea concludes that hepatotoxicity may occur with high doses, the safe level in adults being 338 mg of EGCG daily when taken as pills or powder and 704 mg daily in tea preparations in beverage form). 29580974

## OTHER REFERENCE LINKS

1. Recent References on Herbalife: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Herbalife/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Herbalife: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Herbalife)